# Crinecerfont

## OVERVIEW

### Introduction

Crinecerfont is small molecule inhibitor of the corticotropin releasing factor receptor which is used to treat patients with congenital adrenal hyperplasia. Crinecerfont is has not been associated with significant elevations in serum aminotransferase levels during therapy or with instances of clinically apparent liver injury.

### Background

Crinecerfont (kri” ne ser’ font) is a small molecule inhibitor of the corticotropin-releasing factor (CRF) receptor that blocks the production of adrenocorticotropic hormone (ACTH) and consequent release of adrenal hormones including glucocorticoids (cortisol), mineralocorticoids (aldosterone), and androgen and estrogen precursor molecules such as androstenedione. Classical congenital adrenal hyperplasia is due to a deficiency in 21-hydroxylase, which results in cortisol deficiency that subsequently leads to increased levels of ACTH, excessive stimulation of the adrenals, and overproduction of androgens. While the cortisol deficiency and risk of adrenal crises can be managed with glucocorticoids, the overproduction of androgen leads to growth acceleration, atypical genitalia, hirsutism and acne (in females), precocious puberty, early growth-plate fusion, short stature, and infertility. High doses of glucocorticoids can decrease androgen production to some extent but come with dose limiting side effects. Crinecerfont allows for lower daily glucocorticoid therapy by decreasing ACTH production, adrenal hyperplasia, and androgen overproduction. In placebo-controlled trials in patients with congenital adrenal hyperplasia, crinecerfont was found to lower hormone levels (corticotropin, androstenedione, 17-hydroxyprogesterone) and decrease corticosteroid dose requirements often to physiologic doses. Crinecerfont was approved in the United States in 2024 for use in children and adults with congenital adrenal hyperplasia and is available in capsules of 25, 50, and 100 mg and as an oral solution of 50 mg/mL under the brand name Crenessity. The recommended dose in adults is 100 mg twice daily with meals. In children, the dose is weight-based twice daily with meals. Common side effects may include fatigue, headaches, dizziness, decreased appetite, abdominal pain, back pain, arthralgia, and myalgia. Less common but potentially severe adverse events include hypersensitivity reactions such as rash and angioedema, suicidal ideation and behaviors, and adrenal insufficiency because of inadequate glucocorticoid replacement dosage. Glucocorticoids must be continued during crinecerfont therapy at replacement doses. Increase in dose may be needed during periods of stress or infections.

### Hepatotoxicity

In registration clinical trials, liver test abnormalities were infrequent during crinecerfont therapy and no more common than with placebo. There were no instances of ALT or AST elevations above 3 times the upper limit of normal (ULN) and no cases of liver injury with jaundice or symptoms. Clinical experience with crinecerfont therapy has been limited, but there have no published reports of clinical apparent liver injury with its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which crinecerfont might cause serum aminotransferase elevation is not known. It is a small molecule and is metabolized in the liver, largely via CYP 3A4. Crinecerfont is susceptible to drug-drug interactions with moderate or strong CYP 3A4 inducers requiring dose increases, and they should be avoided if possible.

### Outcome and Management

The serum aminotransferase elevations that occurred on crinecerfont therapy were infrequent and not considered due to the drug therapy. Elevations of ALT or AST found during therapy should lead to search for the cause of the abnormalities. Any aminotransferase elevations with symptoms or jaundice should lead to at least temporary discontinuation until the injury has resolved or the alternative cause identified.

Drug Class: Genetic Disorder Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Crinecerfont – Crenessity®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Crinecerfont)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Crinecerfont | 752253-39-7 | C27-H28-ClFN2-OS

## ANNOTATED BIBLIOGRAPHY

References updated: 17 February 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity published in 1999, before the availability of crinecerfont).
Schimmer BP, Funder JW. Adrenocorticotropic hormone, adrenal steroids, and the adrenal cortex. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 845-861. (Textbook of pharmacology and therapeutics).
FDA: Integrated Review. 2024. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2025/218808Orig1s000,218820Orig1s000IntegratedR.pdf (FDA website with product labels and the FDA review of data on its efficacy and safety of crinecerfont submitted by the sponsor in support of its approval as therapy of congenital adrenal hyperplasia, mentions that crinecerfont caused liver enlargement in rodents, but that in two registration trials, elevations in ALT, AST, and alkaline phosphatase were uncommon and no more frequent than with placebo; no patient developed ALT elevations above 3 times ULN and there were no cases of ALT elevations with jaundice)
Merke DP, Auchus RJ. Congenital adrenal hyperplasia due to 21-hydroxylase deficiency. N Engl J Med. 2020;383:1248-1261. (Review of the epidemiology, clinical features, complications, etiology, genetics, and management of congenital adrenal hyperplasia, the classical form of which is caused by 21-hydroylase deficiency, a P450 enzyme that is responsible for synthesis of cortisol and aldosterone, for which all newborns in the U.S. are screened at birth, and is fatal if untreated with glucocorticoids and sometimes with mineralocorticoids as well, but is still marked by complications of the excess androgen production). 32966723
Newfield RS, Sarafoglou K, Fechner PY, Nokoff NJ, Auchus RJ, Vogiatzi MG, Jeha GS, et al. Crinecerfont, a CRF1 receptor antagonist, lowers adrenal androgens in adolescents with congenital adrenal hyperplasia. J Clin Endocrinol Metab. 2023;108:2871-2878. (Among 8 adolescents with congenital adrenal hyperplasia treated with crinecerfont [50 mg twice daily for 14 days], serum ACTH, 17-hydroxyprogesterone, and androstenedione levels decreased, while adverse events were mostly mild headache and dizziness and “no clinically significant findings were observed in routine laboratory tests”). 37216921
Chrousos GP. Crinecerfont in a first clinical application of a CRH antagonist: further potential uses are still an open chapter! J Clin Endocrinol Metab. 2024;109:e1365-e1366. (History of search for an inhibitor of corticotropin releasing hormone [CRF] for stress related disorders and the ultimate development of crinecerfont as therapy for the elevated levels of CRF in congenital adrenal hyperplasia). 37650613
Sarafoglou K, Kim MS, Lodish M, Felner EI, Martinerie L, Nokoff NJ, Clemente M, et al.; CAHtalyst Pediatric Trial Investigators. Phase 3 trial of crinecerfont in pediatric congenital adrenal hyperplasia. N Engl J Med. 2024;391:493-503. (Among 103 children or adolescents with congenital adrenal hyperplasia treated with crinecerfont for 28 weeks, androstenedione levels decreased by week 4 and were maintained while glucocorticoid doses were reduced by 18%, having increased by 6% with placebo, and there were no hepatic adverse events and “no evident safety concerns related to …clinical laboratory values”). 38828945
Auchus RJ, Hamidi O, Pivonello R, Bancos I, Russo G, Witchel SF, Isidori AM, et al.; CAHtalyst Adult Trial Investigators. Phase 3 trial of crinecerfont in adult congenital adrenal hyperplasia. N Engl J Med. 2024;391:504-514. (Among 182 adults with congenital adrenal hyperplasia treated with crinecerfont or placebo for 24 weeks, androstenedione levels changed by -299 vs +46 ng/dL with placebo, and glucocorticoid doses were reduced by 27% vs 10%, while fatigue and headache were the most common adverse events and “no safety concerns regarding crinecerfont were reported with respect to … clinical laboratory values”). 38828955

## OTHER REFERENCE LINKS

1. Recent References on Crinecerfont: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Crinecerfont/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Crinecerfont: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Crinecerfont)